# Enasidenib

## OVERVIEW

### Introduction

Enasidenib is an orally available small molecule inhibitor of mutant isocitrate dehydrogenase-2 that is used in the therapy of selected cases of acute myelogenous leukemia (AML). Enasidenib is associated with a moderate rate of serum aminotransferase elevations during therapy and is suspected to cause rare instances of clinically apparent acute liver injury.

### Background

Enasidenib (en" a sid' e nib) is a small molecule inhibitor of mutated isocitrate dehydrogenase-2 (IDH2), an enzyme rearranged and mutated in some forms of leukemia and lymphoma. Isocitrate dehydrogenase is an oxidative decarboxylase which is important in maintaining normal progenitor and stem cell differentiation. Mutation in IDH can lead to accumulation of a toxic intermediate (2-hydroxyglutarate; 2-HG) that blocks normal cell differentiation and promotes cancer cell growth. IDH2 mutations are found in 8% to 20% of patients with AML. In cell culture, enasidenib decreased 2-HG levels and restored normal cell differentiation in cancer cells with IDH2 mutations. In several clinical trials enasidenib was found to induce objective responses in a high proportion of patients with refractory AML who harbored mutant IDH2. Enasidenib received accelerated approval for use in refractory or relapsed AML with susceptible IDH2 mutations in 2017. Enasidenib is available in tablets of 50 and 100 mg under the brand name IDHIFA. The recommended initial dose is 100 mg once daily, continued until progression in disease or intolerable toxicity occurs. Side effects are common and frequently severe (77%), leading to dose interruptions (43%), or discontinuations (17%). Common adverse events include diarrhea, nausea and vomiting, abdominal pain, fatigue, and anorexia. Less common but potentially severe side effects include differentiation syndrome, tumor lysis syndrome, and embryo-fetal toxicity.

### Hepatotoxicity

Elevations in serum aminotransferase levels are common during enasidenib therapy, occurring in over half of patients but rising above 5 times the ULN in only 1% to 2%. In addition, enasidenib is an inhibitor of UGT1A1 and is associated with increases in serum indirect (unconjugated) bilirubin in 83% of patients, which rise to levels of 5 to 10 mg/dL in 15% to 20% of subjects. These elevations are not accompanied by serum enzyme elevations and represent indirect (unconjugated) hyperbilirubinemia without liver injury as occurs in patients with Gilbert syndrome. In pooled analysis of prelicensure clinical studies in 345 subjects, there were no cases of clinically apparent liver injury or deaths from liver disease. Since its approval and more widespread use, reports of hepatic failure have been reported in large series of enasidenib treated subjects, but documentation was not always adequate to assess whether the liver injury was related to therapy as opposed to a complication of the underlying leukemia or other treatment.

In prelicensure studies, enasidenib therapy was associated with “differentiation syndrome” in 14% of patients which was sometimes severe and was fatal in at least two instances. Differentiation syndrome is marked by rapid proliferation of activated myeloid cells resulting in release of inflammatory cytokines and symptoms of respiratory distress, accompanied by hypoxia, pulmonary infiltrates, and pleural effusions. Other manifestations include renal impairment, fever, lymphadenopathy, rash, bone pain, peripheral edema, pericardial effusion, coagulopathy, and weight gain. Liver dysfunction can also occur but is generally overshadowed by the more severe systemic manifestations. The onset of differentiation syndrome is generally within 2 to 8 weeks of starting therapy and the course can be severe. Management includes stopping enasidenib and prompt use of corticosteroids in more severe cases. Patients can be restarted on enasidenib once the syndrome resolves.

Likelihood score: D (possible uncommon cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the liver injury due to enasidenib is not known. Enasidenib is metabolized in the liver largely by the cytochrome P450 system (largely CYP 3A4) and is susceptible to drug-drug interactions with inhibitors or inducers of the microsomal enzyme system. Enasidenib is also metabolized by UGT1A1 and competes with bilirubin for conjugation accounting for the frequency of benign hyperbilirubinemia in treated patients. In some instances, serum aminotransferase elevations may arise due to the release of proinflammatory cytokines as a part of the differentiation syndrome.

### Outcome and Management

Enasidenib frequently causes mild-to-moderate transient elevations in serum aminotransferase levels without symptoms or jaundice. Liver injury may also accompany acute differentiation syndrome induced by enasidenib, but therapy has not been linked convincingly to isolated, clinically apparent liver injury or acute liver failure. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose adjustment or temporary discontinuation, which should be permanent if laboratory values do not improve significantly or resolve within a few weeks or if symptoms or jaundice and direct hyperbilirubinemia arise.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Related IDH1 Inhibitors: Ivosidenib, Olutasidenib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Enasidenib – IDHIFA®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Enasidenib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Enasidenib | 1446502-11-9 | C19-H17-F6-N7-O

## ANNOTATED BIBLIOGRAPHY

References updated: 01 March 2025

Abbreviations: AML, acute myeloid leukemia; IDH2, isocitrate dehydrogenase-2.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of kinase inhibitors).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents published in 2013 before the availability of enasidenib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. Multi-Discipline Review. 2017. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2017/209606Orig1s000MultidisciplineR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy).
Kim ES. Enasidenib: first global approval. Drugs 2017; 77: 1705-11. (Review of the mechanism of action, pharmacology, clinically efficacy and safety of enasidenib, a "first-in-class" small molecule inhibitor of IDH2, shortly after its approval for use in AML in the US; mentions that elevations in bilirubin occur in 81% of patients, nausea in 50%, diarrhea 43%, anorexia 34%, vomiting 34%, differentiation syndrome 14% and tumor lysis syndrome 6%; no mention of ALT elevations or hepatotoxicity). 28879540
Stein EM, DiNardo CD, Pollyea DA, Fathi AT, Roboz GJ, Altman JK, Stone RM, et al. Enasidenib in mutant IDH2 relapsed or refractory acute myeloid leukemia. Blood 2017; 130: 722-31. (Dose finding and pilot study of enasidenib in 239 patients with mutant IDH2 positive AML, the complete remission rate was 19% and severe adverse events included hyperbilirubinemia [12%], differentiation syndrome [6%] and tumor lysis syndrome [3%]; no mention of ALT elevations or hepatotoxicity). 28588020
Amatangelo MD, Quek L, Shih A, Stein EM, Roshal M, David MD, Marteyn B, et al. Enasidenib induces acute myeloid leukemia cell differentiation to promote clinical response. Blood 2017; 130: 732-41. (Companion manuscript to Stein [2017] measured mutant IDH2 burden in patients receiving enasidenib showing increases in differentiation of myeloid cells and declines in mutant IDH2 positive cells in recipients of acalabrutinib). 28588019
Yen K, Travins J, Wang F, David MD, Artin E, Straley K, Padyana A, et al. AG-221, a first-in-class therapy targeting acute myeloid leukemia harboring oncogenic IDH2 mutations. Cancer Discov 2017; 7: 478-93. (Description of the discovery of a specific inhibitor of IDH2 [AG-221: enasidenib] using high throughput screening and demonstration of its activity in decreasing the mutant IDH2 induced block in cellular differentiation in human AML cells leading differentiation rather than necrosis of malignant blasts). 28193778
Fathi AT, DiNardo CD, Kline I, Kenvin L, Gupta I, Attar EC, Stein EM, et al.; AG221-C-001 Study Investigators. Differentiation syndrome associated with enasidenib, a selective inhibitor of mutant isocitrate dehydrogenase 2: analysis of a phase 1/2 study. JAMA Oncol 2018; 4: 1106-10. (Among 281 patients with AML treated with enasidenib [50 to 650 mg daily] in open label trials, 33 [12%] were judged to have differentiation syndrome marked by dyspnea, fever, lung infiltrates and hypoxia with onset after 7-129 days [median 30 days], usually responding to corticosteroid therapy, half requiring dose interruption, none dying acutely, and all were able to restart enasidenib after its resolution; no mention of ALT elevations). 29346478
Patel SA. Enasidenib-induced differentiation syndrome in IDH2-mutant acute myeloid leukemia. JAMA Oncol 2018; 4: 1110-1. (Commentary on Fathi [2018] stressing the need to promptly recognize differentiation syndrome and manage it correctly). 29346477
In brief: Two new drugs for AML. Med Lett Drugs Ther 2018; 60 (1543): e56. (Brief summary of the mechanism of action, clinical efficacy, and safety of enasidenib shortly after its approval for use in the US; mentions indirect hyperbilirubinemia without apparent liver toxicity occurring in 38% and differentiation syndrome in 10% of patients [2 of which were fatal] in a pooled analysis of prelicensure clinical trials). 29635267
Mohamed A. Enasidenib-induced Sweet syndrome with differentiation syndrome. Clin Case Rep. 2021;9:e04099. (65 year old woman with IDH2 mutant refractory AML developed fever and rash within one week of starting enasidenib with severe neutropenia and with subsequent pulmonary infiltrates responding to corticosteroid therapy and diagnosed with Sweet and differentiation syndrome). 34026142
DiNardo CD, Schuh AC, Stein EM, Montesinos P, Wei AH, de Botton S, Zeidan AM, et al. Enasidenib plus azacitidine versus azacitidine alone in patients with newly diagnosed, mutant-IDH2 acute myeloid leukaemia (AG221-AML-005): a single-arm, phase 1b and randomised, phase 2 trial. Lancet Oncol. 2021;22:1597-1608. (Among 101 adults with newly diagnosed IDH2 mutant AML treated with azacytidine with or without enasidenib, those receiving both drugs had a better overall response rate than the azacytidine only group [74% vs 36%] but overall survival rates were the same; total and serious adverse event rates [43% vs 44%] were also similar but the addition of enasidenib resulted in higher rates of significant thrombocytopenia, neutropenia, and anemia as well as higher rates of hyperbilirubinemia [19% vs 0%] and differentiation syndrome [10% vs 0%]; no mention of ALT elevations or hepatotoxicity). 34672961
de Botton S, Montesinos P, Schuh AC, Papayannidis C, Vyas P, Wei AH, Ommen H, et al. Enasidenib vs conventional care in older patients with late-stage mutant-IDH2 relapsed/refractory AML: a randomized phase 3 trial. Blood. 2023;141:156-167. (Among 319 adults [ages 60 years or greater] with refractory or relapsed AML with mutated IDH2 treated with enasidenib [100 mg daily] or conventional therapy [azacytidine or cytarabine], event-free survival was longer with enasidenib [4.9 vs 2.6 months] but median overall survival was not different [6.5 vs 6.2 months], and adverse event rates were 77% vs 61%, serious adverse event rates 22% vs 22%, hyperbilirubinemia [not requiring discontinuation] being common with enasidenib [20% vs 1%] as was differentiation syndrome [14% vs none], and one patient on enasidenib died of hepatic failure during the second 28-day cycle, but no details given). 35714312
DiNardo CD, Venugopal S, Lachowiez C, Takahashi K, Loghavi S, Montalban-Bravo G, Wang X, et al. Targeted therapy with the mutant IDH2 inhibitor enasidenib for high-risk IDH2-mutant myelodysplastic syndrome. Blood Adv. 2023;7:2378-2387. (Among 50 adults with myelodysplastic syndrome with IDH2 mutations treated with enasidenib with or without azacytidine, the objective response rate was 58%, and while adverse events were frequent, elevated liver tests arose in only 3 patients [6%], all of which were less than 5 times ULN; no details provided). 35973199
Fu Y, Lv R, Li R, Li W, Guo Z. Safety profile of isocitrate dehydrogenase inhibitors in cancer therapy: a pharmacovigilance study of the FDA Adverse Event Reporting System. Expert Opin Drug Saf. 2025:1-8. (Analysis of spontaneous reports received by the FDA’s Adverse Event Reporting System made between 2018 and 2024; there were 2905 related to enasidenib and 1289 to ivosidenib, the main events being nausea, fatigue, diarrhea, anorexia, decrease in platelet counts, and fever; listings of adverse events arising in more than 10 instances did not include serum aminotransferase elevations or hepatotoxicity). 39727294

## OTHER REFERENCE LINKS

Recent References on Enasidenib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Enasidenib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Enasidenib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Enasidenib)